# Fenofibrate

## OVERVIEW

### Introduction

Fenofibrate is a fibric acid derivative used in the therapy of hypertriglyceridemia and dyslipidemia. Fenofibrate therapy is associated with mild and transient serum aminotransferase elevations and with rare instances of acute liver injury, which can be severe and prolonged and lead to significant hepatic fibrosis.

### Background

Fenofibrate (fen" oh fye' brate) is a fibric acid derivative. Its lipid lowering activity is probably mediated by its interactions with and activation of the peroxisome proliferator activated receptor alpha (PPARα), which regulates gene expression of enzymes involved in fatty acid oxidation. These changes induced by fenofibrate cause an increase in lipoprotein lipase levels which enhance clearance of triglyceride-rich lipoproteins. Fenofibrate is recommended for therapy of adults with severe hypertriglyceridemia and for adults with primary hypercholesterolemia when use of standard agents for lowering low-density lipoprotein cholesterol (LDL-C) is not possible. It has been used off-label to treat primary biliary cirrhosis and sclerosing cholangitis. Fenofibrate was approved for use in Europe in 1975 and in the United States in 1993. Fenofibrate is available in multiple generic forms and under the brand names of Antara, Lipofen, Lofibra, TriCor and Triglide as capsules and tablets of multiple concentrations, typically ranging from 48 to 200 mg each. The recommended initial dosage in adults is 48 to 145 mg daily with dose adjustment to as high as 200 mg daily (depending upon the formulation). Common side effects of fenofibrate include nausea, gastrointestinal upset, headache, muscle cramps, rhinitis, and rash. Laboratory abnormalities can include increases in serum aminotransferase, creatine kinase, and creatinine levels. Fibrates have multiple drug interactions requiring careful review and use. Potential severe adverse events include myopathy and rhabdomyolysis, renal dysfunction, gallstones and their complications, and hypersensitivity reactions including angioedema and anaphylaxis.

### Hepatotoxicity

Mild, transient serum aminotransferase elevations develop in up to 20% of patients receiving fenofibrate, but values above 3 times normal in only 3% to 5%. These abnormalities are usually asymptomatic and transient, resolving even with continuation of fenofibrate, but they occasionally may require drug discontinuation. Monitoring of aminotransferase levels is recommended at baseline and periodically during therapy and discontinuation if enzymes persist above 3 times the upper limit of normal (ULN) or if symptoms of liver injury arise.

There have also been multiple reports of clinically apparent liver injury in patients on fenofibrate. Onset of injury is variable; cases resembling acute hepatitis usually arise within a few weeks or months of starting therapy (Case 2), whereas cases resembling chronic hepatitis and cirrhosis typically arise after more than 6 months or even years of treatment (Case 1). The pattern of serum enzyme elevations is typically hepatocellular, but both mixed and cholestatic patterns have also been described. Some instances of acute injury with a short latency (2 to 8 weeks) are associated with fever, rash and eosinophilia, suggesting immunoallergic hepatitis. Cases with a longer latency typically present with nonspecific symptoms of weakness and fatigue, have autoimmune features with hyperglobulinemia, smooth muscle or antinuclear antibody, and a chronic hepatitis-like clinical and histological picture that is sometimes prolonged and associated with significant fibrosis or cirrhosis.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatotoxicity of fenofibrate is not known but appears to be immunologic. Cases of autoimmune-like hepatitis due to fenofibrate suggest that there is induction of immune reactivity to altered metabolites or fenofibrate-protein haptens in the liver. One small series found the rare, extended HLA haplotype A*33:01, B*14:02, C*08:02, in 3 of 7 patients, all of whom had acute self-limited disease and presented with jaundice and cholestatic or mixed enzyme elevations within 5 to 7 weeks of starting fenofibrate for hypertriglyceridemia. The 4 cases with longer durations of therapy did not share this HLA haplotype.

### Outcome and Management

Several instances of chronic liver injury and fibrosis have been reported with fenofibrate use, typically in patients who were continued on therapy despite evidence of liver injury. However, in most cases, serum aminotransferase levels fall to normal within 2 to 12 months of stopping. Rechallenge is usually followed by recurrence of liver injury and should be avoided. While many cases of fenofibrate associated liver injury have been prolonged and severe, there have been no instances of acute liver failure due to the fibrates. Chronic injury with vanishing bile duct syndrome may underlie many of the instances of chronic liver disease due to fenofibrate. In other instances, features of autoimmune hepatitis are present (ANA, SMA or high immunoglobulin levels). Corticosteroids have been used with apparent effect on serum enzyme levels, but their efficacy in altering the outcome of injury is less clear. If corticosteroids are used, the dose and duration of therapy should be kept to a minimum. Although not proven, there may be some degree of cross sensitivity to hepatic injury among the different fibrates.

Drug Class: Antilipemic Agents, Fibrates

## CASE REPORTS

### Case 1. Acute hepatitis due to fenofibrate therapy.(1)

A 74 year old woman developed jaundice having been on oral therapy with fenofibrate (200 mg daily) for two years. She was not taking other medications and had no history of liver disease, alcohol use, or exposures to hepatitis. On hospital admission, physical examination revealed jaundice but no fever or rash. Laboratory findings included marked elevations in serum aminotransferase levels (Table) and bilirubin of 4.7 mg/dL. Tests for hepatitis A and B were negative, as were autoantibodies. Abdominal ultrasound and endoscopic retrograde cholangiopancreatography showed no evidence of biliary obstruction. During the first week in the hospital, serum bilirubin rose to 13.3 mg/dL and prothrombin time decreased to 46% of normal. At this point, fenofibrate was stopped and she then began to improve, with rapid regression of jaundice, allowing her to be discharged after 25 days in the hospital. In follow up over the next year, all abnormal liver tests returned to normal.

#### Key Points

Medication: | Fenofibrate (200 mg daily)
Pattern: | Hepatocellular (R=12)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 years
Recovery: | 2 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST; (U/L) | GGT; U/L | Bilirubin; (mg/dL) | Other
Started on fenofibrate for hyperlipidemia
2 years | 0 | 1430 | 142 | 4.6 | Alk P=315 (6-fold elevated)
+7 days | 0 | 900 | 160 | 12.5
+10 days | 0 | 800 | 160 | 13.3 | Fenofibrate stopped
| 4 days | 540 | 200 | 12.8
| 8 days | 400 | | 11.3
| 12 days | 440 | | 8.8
| 1 month | | 23 | 4.3
| 2 months | | 30 | 0.7
Normal Values | | <20 | <25 | <1.2

#### Comment

This elderly woman developed a moderately severe, acute hepatocellular injury years after starting fenofibrate therapy, a distinctly unusual latency for drug-induced liver injury, but not inconsistent with other reports of fenofibrate hepatotoxicity. The hepatic injury was severe and associated with prolongation of prothrombin time and worsening liver function tests. Liver biopsy was not performed, but most cases of fenofibrate induced liver injury with a prolonged time to onset have been associated with hepatic fibrosis and, in some cases, cirrhosis. Ultimate recovery and return of serum enzyme levels into the normal range is typical even in cases with chronic hepatitis and cirrhosis.

### Case 2. Acute hepatitis due to fenofibrate.(2)

A 61 year old man with diabetes, hyperlipidemia and hypertension was started on fenofibrate (300 mg daily) and developed dark urine and fatigue two weeks later. After another two weeks, he presented to his physician and was found to be jaundiced. Fenofibrate was stopped, and he was admitted for evaluation. Serum aminotransferase and alkaline phosphatase levels were elevated, and total bilirubin was 9.3 mg/dL (Table). Tests for markers of acute hepatitis A, B and C were negative. Serum autoantibodies were not detected. An abdominal ultrasound and endoscopic retrograde cholangiography showed no evidence of biliary obstruction. A liver biopsy showed intrahepatic cholestasis, mild degrees of steatosis, and inflammatory cells and mild fibrosis in portal areas. His liver tests improved slowly and were normal two months later.

#### Key Points

Medication: | Fenofibrate (300 mg daily)
Pattern: | Mixed (R=2.4→1.4)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 weeks
Recovery: | 2 months
Other medications: | Aspirin, glibenclamide, metformin, pravastatin, nifedipine and dipyridamole for several years.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Started on fenofibrate for hyperlipidemia
4 weeks | 0 | 249 | 259 | 9.3 | GGT=1014 U/L
5 weeks | 5 days | 200 | 360 | 8.0 | Given ursodiol
| 8 days | 115 | 300 | 4.9
6 weeks | 12 days | 55 | | 3.4
| 15 days | 30 | 260 | 3.0
8 weeks | 4 weeks | 20 | 160 | 2.0
12 weeks | 8 weeks | 25 | 125 | 1.3
Normal Values | | <40 | <100 | <1.2

* Estimated from Figure 1.

#### Comment

This patient developed symptoms of acute hepatitis within 2 weeks of starting fenofibrate and was found to be jaundice when seen two weeks later. The serum enzyme elevations were initially "mixed" but then evolved into a cholestatic pattern. Testing closer to the time of onset (2 weeks before presentation) may have shown a more hepatocellular pattern. Recovery is usually prompt and complete in cases of acute injury due to fenofibrate with a short latency period. This patient was treated with ursodiol which is frequently used in cholestatic liver disease, although its efficacy has not been proven.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fenofibrate – Antara®, Lipofen®, Lofibra®, Tricor®, Triglide®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=fenofibrate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fenofibrate | 49562-28-9 | C20-H21-Cl-O4

## CITED REFERENCES

1 Rigal J, Furet Y, Autret E, Breteau M. [Severe mixed hepatitis caused by fenofibrate? A review of the literature apropos of a case]. Rev Med Interne 1989; 10: 65-7.2655052
2 Ho CY, Kuo TH, Chen TS, Tsay SH, Chang FY, Lee SD. Fenofibrate-induced acute cholestatic hepatitis. J Chin Med Assoc 2004; 67: 245-7.15357112

## ANNOTATED BIBLIOGRAPHY

References updated: 30 June 2025

Abbreviations used: PPARα, peroxisome proliferator-activated receptor alpha; ULN, upper limit of the normal range; PBC, primary biliary cholangitis; PSC, primary sclerosing cholangitis; ANA, antinuclear antibody; SMA, smooth muscle antibody.
Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity of lipid lowering agents including clofibrate, fenofibrate and gemfibrozil, all three of which can lead to mild-to-moderate serum aminotransferase elevations, and which have been associated with hepatic injury).
De Marzio DH, Navarro VJ. Fibrates. Hepatotoxicity of cardiovascular and antidiabetic drugs: fibrates. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 527. (Review of hepatotoxicity of fibrates; fenofibrate is the most commonly implicated fibrate in causing liver injury, which can be severe and prolonged with autoimmune features and the potential for chronicity).
Gurgle HE, Blumenthal DK. Fibric acid derivatives. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 613-615. (Textbook of pharmacology and therapeutics).
de Gennes JL, Truffert J. [Elevation of glutamic-pyruvic transaminases under procetofene treatment of idiopathic hyperlipemia: incidence and significance in 443 treated cases]. Nouv Presse Med 1978; 7: 2398-9. French. PMID: 673817 (Report of 443 patients treated with fenofibrate in a dose of 300-400 mg daily for an average of 1 year, found ALT elevations in 19%, >100 U/L in 3%, and persistence in 4%).
Aron E, Metman EH, Bougnoux P. [Hepatitis due to procetofene? 1 case]. Nouv Presse Med 1979; 8: 783. French. PMID: 461126 (77 year old man developed fatigue shortly after starting fenofibrate; after 3 months, bilirubin was 1.2 mg/dL, ALT 205 U/L, Alk P normal; also on amiodarone, but biopsy showed little fat; resolution in 2 months after stopping).
Couzigou P, Boutillier P, Boisseau C, Faucher P, De Mascarel A, Amouretti M, Beraud C, et al. [Drug-induced hepatitis due to fenofibrate] Therapie 1980; 35: 403. (74 year old woman developed fatigue after 2 years of therapy with fenofibrate [bilirubin 2.9 mg/dL, ALT 75 U/L], with no improvement over following 6 months; no further follow up available). 7423433
Vachon JM. [Hepatitis caused by procetofen]. Nouv Presse Med 1980; 9: 2740. French. PMID: 6107896 (63 year old woman developed fatigue 6 months after starting fenofibrate [bilirubin 1.5 mg/dL, ALT 110 U/L, Alk P 30 U/L], resolving in 7 weeks, recurrence with rechallenge with 1.5 month latency [ALT rising to 207 U/L]).
Fromantin M, Gautier D, Quatre JM, Bon R. Efficacite et tolerance due fenofibrate au cours de traitements a long terme. [Efficacy and tolerance of longterm treatment with fenofibrate]. Therapie 1982; 36: 473-6. (Among 121 patients treated with fenofibrate for 3 years, 10 [9%] had ALT elevations usually arising within 3-4 months of starting, largely mild, transient and asymptomatic). 7292431
Homberg JC, Abuaf N, Helmy-Khalil S, Biour M, Poupon R, Islam S, Darnis F, et al. Drug-induced hepatitis associated with anticytoplasmic organelle autoantibodies. Hepatology 1985; 5: 722-7. (Among 157 patients with drug induced liver disease who were tested for ANA and anti-cytoplasmic autoantibodies, 11% had ANA [methyldopa, papaverine, clometacin and oxyphenisatin], none had AMA, 5 anti-LKM [halothane and ticrynafen], and 21% had SMA [mostly clometacin, fenofibrate, oxyphenisatin and papaverine]; most antibodies decreased in titer and/or disappeared within 6 months of stopping; all 4 fenofibrate cases were SMA positive). 4029887
Migneco G, Mascarella A, La Ferla A, Attianese R. [Clofibrate hepatitis. A case report] Minerva Med 1986; 77: 799-800. (51 year old woman developed abdominal pain and fatigue 3 months after starting clofibrate [bilirubin normal, ALT 210 U/L], rapid resolution on stopping; 4 months later presented again having taken fenofibrate for 1 month [ALT 76 U/L, Alk P normal], and rapid resolution again on stopping). 3714094
Massen H, Furet Y. [Hepatitis caused by fenofibrate] Cah Anesthesiol 1986; 34: 249-50. (77 year old developed jaundice within 2 weeks of starting fenofibrate and allopurinol [bilirubin 5.3 mg/dL, ALT 159 U/L, Alk P 239 U/L], resolution within 7 days of stopping both). 3742311
Roberts WC. Safety of fenofibrate: US and worldwide experience. Cardiol 1989; 76: 169-79. (Review of structure, mechanism of action, preclinical toxicology showing peroxisome proliferation in rodents, and safety in clinical trials; in US trials [n=383] ALT elevations in 4.2% with fenofibrate and 1.6% placebo; rarely required discontinuation; postmarketing surveillance showed 13 cases of hepatitis; no evidence of peroxisome proliferation in human liver biopsies). 2673510
Rigal J, Furet Y, Autret E, Breteau M. [Severe mixed hepatitis caused by fenofibrate? A review of the literature apropos of a case] Rev Med Interne 1989; 10: 65-7. (74 year old developed jaundice 2 years after starting fenofibrate [bilirubin 4.7 mg/dL, ALT 1430 U/L, Alk P 315 U/L], with worsening [bilirubin 8.2 mg/dL] until fenofibrate stopped, and then resolving in 2 months). 2655052
Balfour JA, McTavish D, Heel RC. Fenofibrate. A review of its pharmacodynamic and pharmacokinetic properties and therapeutic use in dyslipidaemia. Drugs 1990; 40: 260-90. (Review of pharmacology, efficacy and safety of fenofibrate). 2226216
Bravo ML, Azagra R, Aguyé A, Freixas M. [Acute hepatitis: an adverse reaction to fenofibrate treatment] Aten Primaria 1992; 10: 697-8. (34 year old man developed asymptomatic elevations in ALT [104 U/L] 6 months after starting fenofibrate; remained elevated 6 and 12 months later before becoming normal, but unclear whether and when fenofibrate was stopped). 1420784
Lelouch S, Pelletier G, Sinico M, Ducreux M, Etienne JP. [Fenofibrate-induced acute hepatitis with pseudo-cholangitis] Gastroenterol Clin Biol 1992; 16: 597-9. (65 year old man developed abdominal pain and fever 1 week after restarting fenofibrate and oxacillin, resolving rapidly on stopping both; pain and fever recurred 2 days after restarting fenofibrate alone [bilirubin ~1.8 mg/dL, ALT 12 times ULN, Alk P near normal], resolving within 1 month of stopping). 1526421
Chatrenet P, Regimbeau C, Ramain JP, Penot J, Bruandet P. [Chronic active cirrhogenic hepatitis induced by fenofibrate] Gastroenterol Clin Biol 1993; 17: 612-3. (59 year old woman developed jaundice 14 months after starting fenofibrate [bilirubin 19.5 mg/mL, ALT 34 times and Alk P 1.5 times ULN, IgG high, ANA negative], resolution over 9 months after stopping; biopsy showed chronic hepatitis and fibrosis). 8253329
Bernard PH, Lamouliatte H, Le Bail B, Bioulac-Sage P, Quinton A, Balabaud C. [Chronic active hepatitis associated with antinuclear antibodies induced by fenofibrate] Gastroenterol Clin Biol 1994; 18: 1048-9. (60 year old woman developed asymptomatic rises in ALT [10.9 times ULN], with normal Alk P and bilirubin 22 months after starting fenofibrate; ANA 1:32,000 and biopsy showing chronic active hepatitis and bridging fibrosis, resolution in 2 months with slow and incomplete decline in ANA). 7705574
Lepicard A, Mallat A, Zafrani ES, Dhumeaux D. Atteinte chronique des canaux biliares interlobulaires induite par le fenofibrate. Gastroenterol Clin Biol 1994; 18: 1033-5. (56 year old woman had asymptomatic rise in GGT [16 times ULN], Alk P [1.5 times ULN], ALT [4.5 times ULN] 5 months after starting fenofibrate, with persistent GGT elevations and biopsy showing mild loss of bile ducts). 7705563
Rouhier ML, Rifflet H, Rifflet I, Oberti F, Vuillemin E, Chevailler A, Calès P. [Painful acute liver involvement related to ingestion of fenofibrate] Gastroenterol Clin Biol 1996; 20: 1137-8. (53 year old female developed severe abdominal pain 36 hours after restarting fenofibrate; rechallenge caused the same pain with elevations in ALT [8 times ULN], Alk P [1.5 times ULN], normal bilirubin levels; rapid resolution; persistent ANA of 1:500). 9033862
Athyros VG, Athyros VG, Papageorgiou AA, Hatzikonstandinou HA, Didangelos TP, Carina MV, Kranitsas DF, et al. Safety and efficacy of long-term statin-fibrate combinations in patients with refractory familial combined hyperlipidemia. Am J Cardiol 1997; 80: 608-13. (389 patients treated with statin and fibrate combination for average of 2.5 years; 1.3% stopped because of ALT >3 times normal, all resolving within 4 weeks; no hepatitis or jaundice reported). 9294990
Ganne-Carrié N, de Leusse A, Guettier C, Castera L, Levecq H, Bertrand HJ, Plumet Y, et al. [Autoimmune hepatitis induced by fibrates] Gastroenterol Clin Biol 1998; 22: 525-9. (Retrospective analysis of 5 patients [4 men, 1 woman] with chronic hepatitis due to fibrates identified between 1989-1996; ages 56-73 years, on fenofibrate [n=3] or ciprofibrate [n=2] for 5-36 months; 2 asymptomatic; none with immunoallergic features or eosinophilia, with bilirubin 0.6-36 mg/dL, ALT 4-26 times ULN; all had ANA 1:200-1:2560; liver biopsy showed active cirrhosis in 3 and chronic hepatitis with fibrosis in 2; hepatitis resolved spontaneously in 2, and 3 required corticosteroid therapy in 2 of whom they could be stopped without relapse). 9762291
Dumortier J, Slim R, Chevallier M, Boillot O, Thaunat J-L, Vaillant E, Vial T, et al. Hepatite aigue severe cirrhogene apres preise de ciprofibrate. Gastroenterol Clin Biol 1999; 23: 1399-1400. (72 year old woman developed fatigue after 3 weeks of ciprofibrate [bilirubin 2.9 mg/dL, ALT 25 times ULN, Alk P 2 times ULN, ANA 1:40]; no improvement after 2 months, liver biopsy showed chronic active hepatitis with fibrosis; corticosteroids caused decrease in ALT, but repeat biopsy showed cirrhosis, slow but ultimate resolution). 10642628
Krempf M, Rohmer V, Farnier M, Issa-Sayegh M, Corda C, Sirugue I, Gerlinger C, et al. Efficacy and safety of micronized fenofibrate in a randomized double-blind study comparing four doses from 200 mg to 400 mg daily with placebo in patients with hypercholesterolemia. Diabet Metabol 2000; 26: 184-91. (Controlled trial of 4 doses of micronized fenofibrate vs placebo for 3 months in 340 patients; decreased triglycerides by 27-41%, ALT elevations above 3 times ULN occurred in 3% on fenofibrate vs 1% on placebo). 10880891
Fartoux-Heymann L, Narcy-Lambare B, Labayle D, Fischer D. [Acute hepatitis and drug dermatitis due to fenofibrate (Secalip)] Ann Med Interne (Paris) 2001; 152: 353-4. (43 year old man developed jaundice, rash and fever 2 weeks after starting fenofibrate [300 mg/day] [bilirubin 7.7 mg/dL, ALT 3.2 times ULN, Alk P 2.6 times ULN, atypical lymphocytes without eosinophilia], with rapid recovery and desquamation after stopping fenofibrate). 11593148
Punthakee Z, Scully LJ, Cuindi MM, Ooi TC. Liver fibrosis attributed to lipid lowering medications: two cases. J Intern Med 2001; 150: 249-54. (63 year old woman developed mild fatigue and abnormal ALT [443 U/L]) 2 years after starting fenofibrate, having been on statins and having normal enzymes for years [Ig G 2.2 g/dL, ANA 1:40, SMA negative], biopsy showed chronic hepatitis and bridging fibrosis; resolved within 2 months of stopping, IgG and ANA falling to normal). 11555130
Sgro C, Clinard F, Ouazir K, Chanay H, Allard C, Guilleminet C, Lenoir C, et al. Incidence of drug-induced hepatic injuries: a French population-based study. Hepatology 2002; 36: 451-5. (Over a 3 year period, 34 cases of drug induced liver injury were identified in a population of 81,301 in France [~14 per 100,000], one case being due to fenofibrate). 12143055
Pichon N, Vincensini JF, Rozière A, Labrousse F, Sautereau D, Pillegand B. [Acute cytolytic and cholestatic hepatitis induced by fenofibrate] Gastroenterol Clin Biol 2003; 27: 947-9. (59 year old man developed jaundice 2 months after starting fenofibrate [bilirubin 6.9 rising to 12.3 mg/dL, AST 5.5 times ULN, Alk P 3 times ULN], resolving within 3 months of stopping). 14631314
Parra JL, Reddy KR. Hepatotoxicity of hypolipidemic drugs. Clin Liver Dis 2003; 7: 415-33. (Review and discussion of individual lipid lowering agents; fenofibrate has been associated with both acute and chronic liver injury including cirrhosis; chronic injury often being accompanied by features of autoimmune hepatitis). 12879992
Alsheikh-Ali AA, Kuvin JT, Karas RH. Risk of adverse events with fibrates. Am J Cardiol 2004; 94: 935-8. (Review of adverse event reports to FDA for gemfibrozil and fenofibrate from 1999-2003; hepatotoxicity report rates were 13 per million for gemfibrozil vs 14.6 per million for fenofibrate). 15464682
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but no case was attributed to fenofibrate or other fibrates). 15390328
Ho CY, Kuo TH, Chen TS, Tsay SH, Chang FY, Lee SD. Fenofibrate-induced acute cholestatic hepatitis. J Chin Med Assoc 2004; 67: 245-7. (61 year old man developed jaundice 2 months after starting fenofibrate [bilirubin 9.3 mg/dL, ALT 249 U/L, Alk P 259 U/L], resolving within 2 months of stopping). 15357112
Ahmed F, Petrovic L, Rosen E, Gonzalez R, Jacobson IM. Fenofibrate-induced cirrhosis. Dig Dis Sci 2005; 50: 312-3. (62 year old man had abnormal liver tests without symptoms 11 months after starting fenofibrate [bilirubin 2.8 mg/dL, ALT 662 U/L, Alk P 57 U/L], resolving slowly upon stopping and biopsy showing cirrhosis with mild activity). 15745090
Keech A, Simes RJ, Barter P, Best J, Scott R, Taskinen MR, Forder P, et al.; FIELD study investigators. Effects of long-term fenofibrate therapy on cardiovascular events in 9795 people with type 2 diabetes mellitus (the FIELD study): randomised controlled trial. Lancet 2005; 366 (9500): 1849-61.16310551
(Among 9795 patients with diabetes treated with fenofibrate or placebo for an average of 5 years, ALT levels >3 times ULN occurred in 0.4% on fenofibrate vs 0.8% on placebo; clinically apparent hepatitis in 6 [0.1%] of both groups) .
Dohmen K, Wen CY, Nagaoka S, Yano K, Abiru S, Ueki T, Komori A, et al. Fenofibrate-induced liver injury. World J Gastroenterol 2005; 11: 7702-3. (66 year old woman with primary biliary cirrhosis developed fever and rise in ALT [40 to 216 U/L] and Alk P [367 to 537 U/L] with eosinophilia [14%], 11 days after starting fenofibrate, liver enzymes falling to baseline 2 weeks after stopping). 16437706
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Analysis of 461 cases of drug induced liver disease 1984 to 2004 in Spanish Registry; 4 cases were attributed to fibrates, but no specific information given). 16083708
Lucena MI, Andrade RJ, Vicioso L, Gonzalez FJ, Pachkoria K, Garcia-Munoz B. Prolonged cholestasis after raloxifene and fenofibrate interaction: a case report. World J Gastroenterol 2006; 12: 5244-6. (60 year old woman developed dark urine 2 weeks after starting fenofibrate [bilirubin 9.6 mg/dL, ALT 241 U/L, Alk P 174 U/L], developing rash and prolonged jaundice [4 months] and persistence of Alk P elevations, with biopsy showing decrease in bile ducts; concurrent therapy with estrogen receptor modulator may have altered course). 16937543
Andrade RJ, Lucena MI, Kaplowitz N, García-Muņoz B, Borraz Y, Pachkoria K, García-Cortés M, et al. Outcome of acute idiosyncratic drug-induced liver injury: Long-term follow-up in a hepatotoxicity registry. Hepatology 2006; 44: 1581-8. (28 of 493 [5.7%] cases of drug induced liver disease were found to have evidence of chronic injury; 2 chronic cholestatic cases were attributed to combinations of fibrates with other agents; gemfibrozil/lovastatin and fenofibrate/raloxifen). 17133470
Tudesq N, Bentournes M. [Hepatitis induced by fibrates] Ann Biol Clin (Paris) 2006; 64: 515-6. French. PMID: 17124754 (79 year old treated with fenofibrate for 4 years developed jaundice and ascites [bilirubin 2.7 mg/dL, ALT 36 U/L, AST 111 U/L, Alk P 639 U/L, IgG 2.4 g/mL, ANA 1:1,280], improving after stopping fenofibrate with jaundice, ascites and enzyme elevations resolving over next few months and ANA titer decreasing to 1:160).
Davidson MH, Armani A, McKenney JM, Jacobson TA. Safety considerations with fibrate therapy. Am J Cardiol 2007; 99 (suppl): 3C-18C. (Review of several safety issues with fibrates; fibrates increase cholesterol levels in bile thus increasing cholesterol saturation; in epidemiologic studies there is a 1.7 increase in relative risk of cholelithiasis in patients on long term fibrates, most clearly shown for clofibrate; no discussion of hepatic injury). 17368275
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 1 case was attributed to fenofibrate, but none to clofibrate or gemfibrozil). 18955056
Hajdu D, Aiglová K, Vinklerová I, Urbánek K. Acute cholestatic hepatitis induced by fenofibrate. J Clin Pharm Ther 2009; 34: 599-602. (50 year old woman developed jaundice 2 weeks after adding fenofibrate to a chronic regimen of atorvastatin and citalopram [bilirubin 31.2 mg/dL, ALT 156 U/L, Alk P 525 U/L, ANA and SMA negative], resolving within one month of stopping fenofibrate). 19744016
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to fibrates). 20949552
Björnsson E, Talwalkar J, Treeprasertsuk S, Kamath PS, Takahashi N, Sanderson S, Neuhauser M, et al. Drug-induced autoimmune hepatitis: clinical characteristics and prognosis. Hepatology 2010; 51: 2040-8. (Retrospective analysis of 261 cases of autoimmune hepatitis, 24 [9%] of which were due to a medication; 11 nitrofurantoin, 11 minocylcine, but none attributed to fibrates). 20512992
Liberopoulos EN, Florentin M, Elisaf MS, Mikhailidis DP, Tsianos E. Fenofibrate in primary biliary cirrhosis: a pilot study. Open Cardiovasc Med J 2010; 4: 120-6. (10 patients with primary biliary cirrhosis were treated either with fenofibrate [n=6] or continued on ursodiol [n=4] for 8 weeks; serum ALT and Alk P improved with fenofibrate therapy and no patient had worsening of disease). 20556204
Roth EM, McKenney JM, Kelly MT, Setze CM, Carlson DM, Gold A, Stolzenbach JC, et al. Efficacy and safety of rosuvastatin and fenofibric acid combination therapy versus simvastatin monotherapy in patients with hypercholesterolemia and hypertriglyceridemia: a randomized, double-blind study. Am J Cardiovasc Drugs 2010; 10: 175-86. (Controlled trial) of several doses of fenofibrate combined with rosuvastatin vs simvastatin alone in 474 patients with hypercholesterolemia; 1% of fenofibrate/rosuvastatin vs 0% of simvastatin treated patients had an ALT elevation >5 times ULN, but none had clinically apparent liver injury). 20524719
Levy C, Peter JA, Nelson DR, Keach J, Petz J, Cabrera R, Clark V, et al. Pilot study: fenofibrate for patients with primary biliary cirrhosis and an incomplete response to ursodeoxycholic acid. Aliment Pharmacol Ther 2011; 33: 235-42. (20 patients with primary biliary cirrhosis with an incomplete response to ursodiol were treated with fenofibrate for 48 weeks; none had worsening of liver disease and mean serum AST and Alk P levels improved). 21083674
Czaja AJ. Drug-induced autoimmune-like hepatitis. Dig Dis Sci 2011; 56: 958-76. (Review of drug induced autoimmune hepatitis, the principal causes being minocycline and nitrofurantoin; other caues being methyldopa, hydralazine, statins, fibrates, diclofenac, anti-TNF agents, interferons, propylthiouracil and isoniazid). 21327704
Farnier M, Marcereuil D, De Niet S, Ducobu J, Steinmetz A, Retterstøl K, Bryniarski L, et al. Safety of a fixed-dose combination of fenofibrate/pravastatin 160 mg/40 mg in patients with mixed hyperlipidaemia: a pooled analysis from a database of clinical trials. Clin Drug Investig 2012; 32: 281-91. (Pooled analysis of 5 large trials of fenofibrate vs a statin vs the combination for 12-64 weeks found ALT >3 times ULN in 1.6% of subjects on fenofibrate and 0.4% on the combination; one patient had "hepatic insufficiency of moderate intensity", but the event was considered "non-serious" because it did not lead to "patient withdrawal"). 22350498
Geng Q, Ren J, Chen H, Lee C, Liang W. Adverse events following statin-fenofibrate therapy versus statin alone: a meta-analysis of randomized controlled trials. Clin Exp Pharmacol Physiol 2013; 40: 219-26. (Systematic review of the safety of the combination of fenofibrate and statins found higher rates of ALT and AST elevations with the combination than with statins alone). 23324122
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, of which 2 were attributed to atorvastatin and 1 to simvastatin, but none to fibrates). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to a fibrates). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 cases [0.5%] were attributed to fenofibrate). 25754159
Cheung AC, Lapointe-Shaw L, Kowgier M, Meza-Cardona J, Hirschfield GM, Janssen HL, Feld JJ. Combined ursodeoxycholic acid (UDCA) and fenofibrate in primary biliary cholangitis patients with incomplete UDCA response may improve outcomes. Aliment Pharmacol Ther. 2016;43:283-93. (In a retrospective analysis, comparison of patients with PBC treated with ursodiol alone [n=66] or combined with fenofibrate [n=66: cohorts matched for age, cirrhosis, Alk P, bilirubin and platelet counts] for a median of 11 months demonstrated greater decreases in Alk P levels and improved decompensation- and transplant-free survival with fenofibrate, but 1 patient developed ALT elevations above 5 times ULN after 5.4 years which resolved upon stopping). 26559762
Hegade VS, Khanna A, Walker LJ, Wong LL, Dyson JK, Jones DEJ. Long-term fenofibrate treatment in primary biliary cholangitis improves biochemistry but not the UK-PBC risk score. Dig Dis Sci. 2016;61:3037-3044. (Among 23 patients with PBC and an incomplete response to ursodiol who were treated with the addition of fenofibrate [200 mg daily] for a median of 21 months, there were sustained improvements in Alk P levels, but no improvement in the UK-PBC risk scores for decreasing liver-related deaths or liver transplantations). 27435324
Ahmad J, Odin JA, Hayashi PH, Chalasani N, Fontana RJ, Barnhart H, Cirulli ET, et al. Identification and characterization of fenofibrate-induced liver injury. Dig Dis Sci. 2017;62:3596-3604. (Among 1229 cases of confirmed drug-induced liver injury enrolled in a U.S. prospective study between 2004 and 2015, 7 [0.6%] were attributed to fenofibrate, 3 after a short duration of therapy [5 to 7 weeks] and 4 with longer duration [16 to 56 weeks], short latency being associated with a self-limited, moderate course and HLA-A*33:01 in all 3 cases, while long duration courses were likely to have a more extended and severe course and were without the HLA-A*33:01 allele). 29119413
Hedrington MS, Davis SN. Peroxisome proliferator-activated receptor alpha-mediated drug toxicity in the liver. Expert Opin Drug Metab Toxicol. 2018;14:671-677. (Review of the hepatotoxicity of fibrates, including fenofibrate, clofibrate, gemfibrozil and bezafibate, concludes that “compelling evidence of fibrate-induced hepatotoxicity is not available, and that clinically apparent liver injury has been shown by single case reports for fenofibrate, clofibrate, and gemfibrozil but not for bezafibrate). 29847748
Ma S, Liu S, Wang Q, Chen L, Yang P, Sun H. Fenofibrate-induced hepatotoxicity: a case with a special feature that is different from those in the LiverTox database. J Clin Pharm Ther. 2020;45:204-207. (65 year old Chinese man developed symptomatic acute liver injury within 3 days of starting fenofibrate [200 mg daily] with sudden rise in liver tests [bilirubin 0.7 to 1.9 mg/dL, ALT 20 to 1136 U/L, Alk P 118 to 280 U/L, GGT 40 to 335 U/L] and rapid improvement after stopping with normal values 2 weeks later). 31518450
Ghonem NS, Auclair AM, Hemme CL, Gallucci GM, de la Rosa Rodriguez R, Boyer JL, Assis DN. Fenofibrate improves liver function and reduces the toxicity of the bile acid pool in patients with primary biliary cholangitis and primary sclerosing cholangitis who are partial responders to ursodiol. Clin Pharmacol Ther. 2020;108:1213-1223. (In a retrospective analysis of 31 patients with PBC or PSC with an incomplete response to ursodiol therapy who had the addition of fenofibrate [160 mg daily], alkaline phosphatase levels fell into the normal range in 84% and total serum bile acid levels improved as well). 32480421
Chen YQ, Zhao SP, Ye HJ. Efficacy and safety of coenzyme A versus fenofibrate in patients with hyperlipidemia: a multicenter, double-blind, double-mimic, randomized clinical trial. Curr Med Res Opin. 2020;36:941-945. (Among 417 Chinese adults with hypertriglyceridemia treated with fenofibrate [200 mg] or coenzyme A [400 mg] daily for 8 weeks, triglyceride levels fell by 33% vs 24% and total cholesterol by 3% in both while adverse events were more frequent with fenofibrate including gastrointestinal symptoms [9.7% vs 1.4%] and aminotransferase elevations [4.3% vs 0.5%]; no mention of serious adverse events or clinically apparent liver injury ). 32212983
Lee HY, Lee AR, Yoo JJ, Chin S, Kim SG, Kim YS. Biopsy-confirmed fenofibrate-induced severe jaundice: A case report. World J Clin Cases. 2021;9:9295-9301. (65 year old Korean man was found to have abnormal liver tests a month after starting fenofibrate in a dose of 135 mg daily [bilirubin 16.0 mg/dL, ALT 172 U/L, Alk P 1182 U/L, INR 0.9] with improvement upon stopping and use of prednisolone). 34786416
Li C, Zheng K, Chen Y, He C, Liu S, Yang Y, Li M, et al. A randomized, controlled trial on fenofibrate in primary biliary cholangitis patients with incomplete response to ursodeoxycholic acid. Ther Adv Chronic Dis. 2022;13:20406223221114198. (Among 48 patients with PBC refractory to ursodiol treated with the combination of ursodiol and fenofibrate [200 mg] vs ursodiol alone for 12 months, Alk P, GGT, and bilirubin levels were normal at 12 months in 21% receiving the combination vs none on ursodiol alone, while one fenofibrate treated patient stopped therapy after 3 months because of ALT levels above 10 times ULN, that later required corticosteroid therapy). 35924008
Lipid-lowering drugs. Med Lett Drugs Ther. 2022;64(1659):145-152. (Concise review of drugs for dyslipidemia states that fenofibrate is used largely for hypertriglyceridemia but has not been shown to improve cardiovascular outcomes, commonly causes gastrointestinal side effects, can cause cholelithiasis, hepatitis, and myositis, and concludes that “fibrates are contraindicated in patients with liver or gallbladder disease”). 36094548
Ding D, Guo G, Liu Y, Zheng L, Jia G, Deng J, Sun R, et al. Efficacy and safety of fenofibrate addition therapy in patients with cirrhotic primary biliary cholangitis with incomplete response to ursodeoxycholic acid. Hepatol Commun. 2022;6:3487-3495. (Among 59 Chinese patients with cirrhosis due to PBC refractory to ursodiol therapy who had addition of fenofibrate vs continuation on ursodiol alone in a retrospective study, Alk P levels fell into the normal range in 37% vs 11%, and in follow up, rates of liver decompensation were less [40% vs 48%], and “no significant adverse events associated with additional fenofibrate therapy were observed”). 36213941
Ding D, Ren P, Guo G, Liu Y, Yang C, Zheng L, Jia G, et al. Fenofibrate normalizes alkaline phosphatase and improves long-term outcomes in patients with advanced primary biliary cholangitis refractory to ursodeoxycholic acid. Gastroenterol Hepatol. 2023;46:692-701. (Among 118 Chinese patients with advanced PBC refractory to ursodiol therapy who had addition of fenofibrate vs continuation on ursodiol alone in a retrospective study, Alk P levels fell into the normal range in 37% vs 11%, and in follow up, rates of hepatic decompensation were less [34% vs 54%], and “no fenofibrate-related significant adverse events were observed”). 36632973
Liu Y, Guo G, Zheng L, Sun R, Wang X, Deng J, Jia G, et al. Effectiveness of fenofibrate in treatment-naive patients with primary biliary cholangitis: a randomized clinical trial. Am J Gastroenterol. 2023;118:1973-1979. (Among 117 Chinese patients with newly diagnosed PBC treated with ursodiol alone vs urso and fenofibrate [200 mg daily] for 12 months, Alk P fell into the normal range in 40% vs 62% by 12 months, while ALT elevations arose in 8% vs 19%, none were above 5 times ULN and all resolved spontaneously). 36892506
Younis IR, Weber EJ, Nelson C, Qin AR, Watkins TR, Othman AA. Pharmacokinetics and safety of fenofibrate in participants with mild hepatic impairment or with advanced fibrosis due to metabolic-associated fatty liver disease. J Clin Pharmacol. 2025;65:850-859. (Pharmacokinetic studies of fenfibrate in 41 patients with nonalcoholic fatty liver disease demonstrated no clinically meanfingful effects of mild hepatic impairment but an 60% to 80% increase in levels in patients with advanced fibrosis of compensated cirrhosis). 40052566

## OTHER REFERENCE LINKS

1. Recent References on Fenofibrate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=fenofibrate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Fenofibrate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fenofibrate)